# Crizanlizumab

## OVERVIEW

### Introduction

Crizanlizumab is a humanized monoclonal antibody to P-selectin which is used to prevent painful crises in sickle cell disease. Crizanlizumab is generally well tolerated and has not been associated with serum aminotransferase elevations during therapy or with instances of clinically apparent liver injury.

### Background

Crizanlizumab (kriz an liz ue mab) is a humanized monoclonal IgG2 antibody directed against P-selectin, which is used to prevent painful, vaso-occlusive crises in patients with sickle cell disease. Sickle cell disease is caused by an inherited mutation in the β globin gene that creates hemoglobin S, which is prone to aggregation with deoxygenation resulting in deformation and sickling of red blood cells, hemolytic anemia, and recurrent painful crises involving different organs and tissues. Sickle cell disease affects at least 100,000 Americans and is most common in persons of African descent. Long term complications include disability due to recurrent painful crises, acute chest syndrome, pulmonary hypertension, stroke and cerebral infarcts, end-organ damage and early mortality. Binding of the monoclonal antibody to P-selectin inhibits its attachment to its glycoprotein ligand thereby inhibiting the adhesion of sickled red cells to endothelium, a critical step in the vaso-occlusive crises of sickle cell disease. Thus, crizanlizumab does not prevent sickling of red cells or increase hemoglobin levels or change the oxygen-binding characteristics of hemoglobin, but rather it inhibits the aggregation and binding of the sickled red cells to platelets, leukocytes and endothelial cells which mediates the vascular occlusions that underlie painful crises. In preregistration randomized, placebo-controlled trials, 48 weeks of crizanlizumab therapy resulted in a decrease in the number of painful crises and both duration and numbers of hospitalizations. Crizanlizumab was approved in the United States in 2019 as therapy for prevention of painful crises in sickle cell disease in adults and children above the age of 16 years. Crizanlizumab is available in single dose pre-filled syringes 100 mg in 10 mL (10 mg per mL) under the brand name Adakveo. The recommended dose is 5 mg/kg intravenously over 30 minutes at 0 and 2 weeks, followed by every 4 weeks thereafter. Crizanlizumab can be given with hydroxyurea, the standard therapy for sickle cell disease. Common side effects of crizanlizumab include mild local injection reactions, arthralgias, backpain, diarrhea, pruritus, nausea, vomiting and chest pain. Also reported have been rare instances of severe hypersensitivity reactions.

### Hepatotoxicity

Mild-to-moderate serum aminotransferase elevations arise a small percentage of treated patients, but are generally asymptomatic and transient and rarely necessitate discontinuation of crizanlizumab injections. In registration trials of crizanlizumab there were no reported instances clinically apparent liver injury or severe hepatic adverse events attributed to the therapy. Since approval and more general use of crizanlizumab there have been no reports of clinically significant liver injury attributed to its use.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

Possible mechanisms of liver injury due to crizanlizumab are not known. Monoclonal antibodies and immunoglobulins are generally taken up and metabolized intracellularly to short peptides and amino acids.

### Outcome and Management

Drug Class: Genetic Disorder Agents, Monoclonal Antibodies, Sickle Cell Disease Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Crizanlizumab – Adakveo®

DRUG CLASS

Sickle Cell Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Crizanlizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Crizanlizumab | 1690318-25-2 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 12 July 2021

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of crizanlizumab).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/761128Orig1s000MultidisciplineR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA multidisciplinary scientific review of the crizanlizumab application which mentions safety results in 175 patients treated with crizanlizumab for an average of 42 weeks, there were no treatment-related hepatobiliary adverse events or episodes of drug induced liver injury or jaundice).
Koh C, Turner T, Zhao X, Minniti CP, Feld JJ, Simpson J, Demino M, et al. (2013). Liver stiffness increases acutely during sickle cell vaso-occlusive crisis. Am J Hematol. (Among 23 patients with sickle cell disease evaluated before and during an acute vaso-occlusive crisis, serum liver enzyme elevations did not change appreciably but hepatic stiffness increased [measured by ultrasound transient elastography] as did serum total and indirect bilirubin and reticulocyte counts, while serum albumin and hemoglobin decreased).
Feld JJ, Kato GJ, Koh C, Shields T, Hildesheim M, Kleiner DE, Taylor JG, et al. (2015). Liver injury is associated with mortality in sickle cell disease. Aliment Pharmacol Ther. (Among 247 patients with sickle cell disease, liver disease was common, elevations in ALT were present in 16% and alkaline phosphatase in 33%; factors associated with mortality during follow up were iron indices [serum ferritin, transferrin, and iron] and liver abnormalities [direct bilirubin, albumin and alkaline phosphatase levels]; liver biopsy done in 40 patients revealed nodular regenerative hyperplasia in 36% and portal venopathy in 23%).
Ataga KI, Kutlar A, Kanter J, Liles D, Cancado R, Friedrisch J, Guthrie TH, et al. (2017). Crizanlizumab for the prevention of pain crises in sickle cell disease. N Engl J Med. (Among 198 patients with sickle cell disease treated with crizanlizumab [2.5 or 5.0 mg/kg] or placebo subcutaneously in 14 injections over 48 weeks, the number of pain crises and duration of hospitalizations decreased with crizanlizumab, while hemoglobin levels and reticulocyte counts did not change and adverse events were more frequent with active therapy but usually mild-to-moderate in severity [arthralgia, diarrhea, vomiting, pruritus and chest pain]; no mention or listing of ALT elevations or hepatotoxicity).
(2020). Two drugs for sickle cell disease. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of crizanlizumab and voxelotor shortly after their approval for use in sickle cell disease in the US; no mention of ALT elevations or hepatotoxicity).
Blair HA. (2020). Crizanlizumab: first approval. Drugs. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and adverse side effects of crizanlizumab shortly after its approval for use in sickle cell disease in the US, mentions adverse events of arthralgia, back pain, diarrhea, nausea, pruritus, fever and chest pain, but not ALT elevations or hepatotoxicity; infusion reactions arose in 3% of cases).
Osunkwo I, Manwani D, Kanter J. (2020). Current and novel therapies for the prevention of vaso-occlusive crisis in sickle cell disease. Ther Adv Hematol. (Review of the pathogenesis of vaso-occlusive crises in sickle cell disease and drugs that target different components of the multifactorial process including increasing fetal hemoglobin [hydroxyurea], decreasing oxidative stress [L-glutamine], increasing oxygen affinity of hemoglobin [voxelotor], and decreasing adhesion of sickled cells to platelets, neutrophils and endothelium [crizanlizumab]; no mention of ALT elevations with therapy or hepatotoxicity).
Darbari DS, Sheehan VA, Ballas SK. (2020). The vaso-occlusive pain crisis in sickle cell disease: definition, pathophysiology, and management. Eur J Haematol. (Extensive review of the pathogenesis of vaso-occlusive crisis in patients with sickle cell disease and therapies that target different steps in the process including inflammation, adhesion, oxygen affinity and stability of hemoglobin, and oxidative stress; discusses efficacy of L-glutamine, voxelotor and crizanlizumab, mentioning that all three are well tolerated; no mention or discussion of hepatotoxicity).
Ali MA, Ahmad A, Chaudry H, Aiman W, Aamir S, Anwar MY, Khan A. (2020). Efficacy and safety of recently approved drugs for sickle cell disease: a review of clinical trials. Exp Hematol. (Review of randomized controlled trials of 3 recently approved drugs for sickle cell disease focusing upon L-glutamine, voxelotor, and crizanlizumab states that all three are “well tolerated without any alarming adverse effects”; no mention of ALT elevations or hepatotoxicity).
Gardner RV. (2020). Crizanlizumab in vaso-occlusive crisis caused by sickle cell disease. Drugs Today (Barc). (Review of clinical efficacy and safety of crizanlizumab; no mention of ALT elevations or hepatotoxicity).
Tisdale JF, Thein SL, Eaton WA. (2020). Treating sickle cell anemia. Science. (Review of mechanism of action and efficacy of current and the promise of future therapies of sickle cell anemia, mentions that prevention of adhesion may prevent sickle crises by delaying the time to vasculature obstruction relative to the time of transit of the red cells through the capillaries).
Pace BS, Starlard-Davenport A, Kutlar A. (2021). Sickle cell disease: progress towards combination drug therapy. Br J Haematol. (Review of the pathophysiology of sickle cell disease and vaso-occlusive crises and mechanism of action of drugs used to treat sickle cell disease and drugs currently under investigation for efficacy in decreasing the microvascular occlusive crises that mediate much of the morbidity and mortality of this disease).

## OTHER REFERENCE LINKS

1 Recent References on Crizanlizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Crizanlizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Crizanlizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Crizanlizumab)